# Zilucoplan

## OVERVIEW

### Introduction

Zilucoplan is a macrocyclic peptide inhibitor of complement component 5 (C5) used in the treatment of myasthenia gravis in adults who have antibodies to the acetylcholine receptor. Zilucoplan has not been associated with serum aminotransferase elevations during therapy or with clinically apparent liver injury.

### Background

Zilucoplan (zil” ue koe’ plan) is a 15–amino-acid, synthetic macrocyclic peptide that inhibits the terminal complement cascade by binding to complement component 5. It acts by a dual mechanism, blocking cleavage of C5 into C5a and C5b and binding to C5b preventing its interaction with C6 which results in failure of assembly of the last steps that create the membrane attack complex (C5b-9). Myasthenia gravis is an autoimmune condition in which autoantibodies to the acetylcholine receptor (AChR) block neurotransmission resulting in muscle weakness, including drooping of the eye lids, change in facial expression, difficulty swallowing and breathing, and weakness of arms, hands, and legs. Reduction of complement-mediated injury at the neuromuscular junction of acetylcholine receptors is believed to underlie the benefit of zilucoplan in myasthenia gravis that was documented in preregistration clinical trials. Zilucoplan was approved for use in the United States in 2023 for the treatment of generalized myasthenia gravis in adults who are positive for serum antibodies to the acetylcholine receptor (anti-AChR). It is available as a solution in single-dose prefilled syringes of 16.6, 23.0, and 32.4 mg under the brand name Zilbrysq. The usual dose is a single subcutaneous self-injection once daily, with the strength selected by body weight. Because zilucoplan is a complement inhibitor, it carries a boxed warning for serious and life-threatening bacterial infections, particularly meningococcal infections. Zilucoplan is available only through a restricted distribution program in which patients must be vaccinated against meningococcal disease before starting therapy and monitored for symptoms of meningococcal infection. Side effects of zilucoplan are generally mild and can include injection-site reactions, headache, diarrhea, nausea, upper respiratory and urinary tract infections, and laboratory elevations in serum lipase and amylase. Rare but potentially serious adverse events include meningococcal and other invasive infections, hypersensitivity reactions, and pancreatitis and pancreatic cysts.

### Hepatotoxicity

In the pre-registration controlled trials, serum aminotransferase elevations were not more frequent with zilucoplan than with placebo, and there were no episodes of clinically apparent liver injury. In a 12-week trial in 174 patients with generalized myasthenia gravis, adverse event rates were similar in the two groups apart from more frequent infections and more frequent laboratory elevations of serum lipase and amylase with zilucoplan. One zilucoplan-treated patient discontinued because of a rise in serum liver-related enzymes, but without symptoms or jaundice. The elevations in lipase and amylase reflect a pancreatic rather than hepatic effect of the drug, and pancreatitis and pancreatic cysts have since been reported. In the open-label extension with up to several years of exposure, no signal for hepatotoxicity emerged. Zilucoplan has also been evaluated in other autoimmune and neurodegenerative conditions, including immune-mediated necrotizing myopathy, amyotrophic lateral sclerosis, and paroxysmal nocturnal hemoglobinuria; in none was zilucoplan linked to aminotransferase elevations or clinically apparent liver injury. Since approval, there have been no published cases of liver injury attributed to zilucoplan, but clinical experience with its use has been limited.

Likelihood score: E (unlikely cause of clinically apparent liver injury).

### Mechanism of Injury

Zilucoplan is a large-molecule-weight peptide that is degraded to small peptides and amino acids by catabolic pathways in many tissues, rather than being extensively metabolized in the liver to potentially reactive intermediates. The complement-inhibiting activity of zilucoplan is unlikely in itself to cause liver injury.

### Outcome and Management

Zilucoplan has not been linked to serum aminotransferase elevations during therapy or to clinically apparent liver injury, and routine monitoring of liver tests is not recommended in the product label. There is no information on cross-sensitivity to hepatic injury among the other agents for myasthenia gravis or the complement inhibitors, but the differences in their structure and mechanisms of action suggest that switching among these agents is likely to be safe.

Drug Class: Myasthenia Agents, Complement Inhibitors

Other Drugs in the Subclass: Eculizumab, Ravulizumab, Pegcetacoplan

## PRODUCT INFORMATION

REPRESENTATIVE TRADE NAMES

Zilucoplan – Zilbrysq®

DRUG CLASS

Neurologic Agents

COMPLETE LABELING (https://dailymed.nlm.nih.gov/dailymed/search.cfm?labeltype=all&query=Zilucoplan)

Product labeling at DailyMed, National Library of Medicine, NIH

## CHEMICAL FORMULA AND STRUCTURE

DRUG | CAS REGISTRY NUMBER | MOLECULAR FORMULA | STRUCTURE
Zilucoplan | 1841136-73-9 | C172H278N24O55 | SID:381128102

## ANNOTATED BIBLIOGRAPHY

References updated: 28 September 2026

Abbreviations used: AChR, acetylcholine receptor; C5, complement component 5; sc, subcutaneously.

Zimmerman HJ. Hepatotoxicity: the adverse effects of drugs and other chemicals on the liver. 2nd ed. Philadelphia: Lippincott, 1999. (Expert review of hepatotoxicity published in 1999, before the availability of zilucoplan and other complement inhibitors).
https://www.accessdata.fda.gov/drugsatfda_docs/nda/2023/216834Orig1s000IntegratedR.pdf (FDA website with product labels and FDA review of data on efficacy and safety of zilucoplan, submitted by the sponsor in support of its approval as therapy of adults with myasthenia gravis, mentions that there were no serious drug related hepatic disorders although ALT elevations above 5 times ULN occurred in one zilucoplan-treated patient who discontinued therapy early for liver test abnormalities with ALT of 288 U/L, AST 226 U/L, Alk P 263 U/L, GGT 470 U/L, and bilirubin 0.4 mg/dL at day 38, but no clinical details and little follow up were provided).
Howard JF Jr, Nowak RJ, Wolfe GI, Freimer ML, Vu TH, Hinton JL, Benatar M, et al. Clinical effects of the self-administered subcutaneous complement inhibitor zilucoplan in patients with moderate to severe generalized myasthenia gravis: results of a phase 2 randomized, double-blind, placebo-controlled, multicenter clinical trial. JAMA Neurol. 2020;77:582-592. (Among 44 patients with AChR-antibody positive myasthenia gravis treated with zilucoplan [0.1 or 0.3 mg/kg] or placebo subcutaneously (sc) once daily for 12 weeks, the 0.3 mg/kg dose reduced myasthenia gravis scores more than placebo [–6.0 vs –3.2], while adverse events were mostly mild injection-site reactions and no serious treatment-related events occurred, with no mention of ALT elevations or hepatotoxicity). 32065623
Howard JF Jr, Vissing J, Gilhus NE, Leite MI, Utsugisawa K, Duda PW, Farzaneh-Far R, et al. Zilucoplan: an investigational complement C5 inhibitor for the treatment of acetylcholine receptor autoantibody-positive generalized myasthenia gravis. Expert Opin Investig Drugs. 2021;30:483-493. (Review of the mechanism of action, pharmacology, and clinical development of zilucoplan as therapy of generalized myasthenia gravis; discusses the tolerability of the peptide but does not mention ALT elevations or hepatotoxicity). 33792453
Mammen AL, Amato AA, Dimachkie MM, Chinoy H, Hussain Y, Lilleker JB, Pinal-Fernandez I, et al. Zilucoplan in immune-mediated necrotizing myopathy: a phase 2, randomised, double-blind, placebo-controlled, multicentre trial. Lancet Rheumatol. 2023;5:e67-e76. (Among 27 patients with autoantibody-positive, immune-mediated necrotizing myopathy treated with zilucoplan [0.3 mg/kg] or placebo daily for 8 weeks, C5 inhibition did not improve muscle strength or creatine kinase levels, and the most frequent adverse events were headache [33% vs 27%] and nausea [25% vs 20%], with no mention of drug-related aminotransferase elevations or hepatotoxicity, although the underlying myopathy itself causes marked aminotransferase elevations of muscle origin). 36923454
Howard JF Jr, Bresch S, Genge A, Hewamadduma C, Hinton J, Hussain Y, Juntas-Morales R, et al.; RAISE Study Team. Safety and efficacy of zilucoplan in patients with generalised myasthenia gravis (RAISE): a randomised, double-blind, placebo-controlled, phase 3 study. Lancet Neurol. 2023;22:395-406. (Among 174 patients with AChR-antibody positive myasthenia gravis treated with zilucoplan [0.3 mg/kg] or placebo sc once daily for 12 weeks, myasthenia gravis activities-of-daily-living scores improved more with zilucoplan [–4.4 vs –2.3], while adverse events were similar in the two groups except for more frequent infections [27% vs 18%] and elevations of serum lipase [6.9% vs 0%] and amylase [4.7% vs 1.1%]; one zilucoplan-treated patient discontinued for an asymptomatic increase in liver-related enzymes, but there were no cases of clinically apparent liver injury or jaundice). 37059508
Röth A, Nishimura JI, Ueda Y, de Castro CM, Fu CL, Fukui M, Kawakami T, et al. Phase II trials of zilucoplan in paroxysmal nocturnal hemoglobinuria. Haematologica. 2024;109:929-935. (Pooled analysis of studies of zilucoplan in paroxysmal nocturnal hemoglobinuria found reductions in serum lactate dehydrogenase with only mild to moderate adverse events, injection-site reactions being the most common; no mention of ALT elevations or hepatotoxicity). 37534517
Zilucoplan (Zilbrysq) for myasthenia gravis. Med Lett Drugs Ther. 2024;66(1700):60-62. (Concise review of the mechanism of action, clinical efficacy, safety, and costs of zilucoplan shortly after its approval as therapy of myasthenia gravis in the United States, discusses common adverse events and its boxed warning about meningococcal infections, but no mention of ALT elevations or hepatoxicity). 38576149
Howard JF Jr, Bresch S, Farmakidis C, Freimer M, Genge A, Hewamadduma C, Hinton J, et al. Long-term safety and efficacy of zilucoplan in patients with generalized myasthenia gravis: interim analysis of the RAISE-XT open-label extension study. Ther Adv Neurol Disord. 2024;17:17562864241243186. (Among 200 patients with myasthenia gravis in an open-label extension of zilucoplan for a median of 1.2 years, adverse events arose in 94%, most often being a worsening of myasthenia gravis [26%] and COVID-19 [25%]; no mention of ALT elevations or drug-induced liver injury). 38638673
Paganoni S, Fournier CN, Macklin EA, Chibnik LB, Quintana M, Saville BR, Detry MA, et al.; HEALEY ALS Platform Trial Study Group. Efficacy and safety of zilucoplan in amyotrophic lateral sclerosis: a randomized clinical trial. JAMA Netw Open. 2025;8:e2459058. (Among 286 patients with amyotrophic lateral sclerosis treated with zilucoplan [0.3 mg/kg] or placebo for 24 weeks, zilucoplan did not slow disease progression and the study was stopped for futility, while adverse events were consistent with other studies and the underlying disease; hepatic enzyme elevation occurred in 1 subject (0.8%) in the zilucoplan group, a rate that was lower than the placebo group). 39960672
Tammam G, Slioui A, Friedman D, Acket B, Cavalli M, Bresch S, Lagrange E, et al. Real-world effectiveness and safety of zilucoplan in patients with anti-AChR myasthenia gravis: A retrospective cohort study in France. J Neuromuscul Dis. 2026:22143602261437792. (Among 48 French patients with myasthenia gravis treated with zilucoplan in an early access program, activity scores decreased from 7.4 to 2.5 at 6 months and corticosteroid use decreased while adverse events arose in 31%, including headache, nausea, and injection site pain, while laboratory abnormalities included eosinophilia in 4, lipase elevations in 4, and lymphopenia in 1; but there were no serious adverse events and no mention of ALT elevations or hepatotoxicity ). 41904994

## OTHER REFERENCE LINKS

1. Recent References on Zilucoplan: from PubMed.gov (https://pubmed.ncbi.nlm.nih.gov/?term=zilucoplan+AND+%22Humans%22%5BMeSH+Terms%5D+AND+%28+%22Chemical+and+Drug+Induced+Liver+Injury%22%5BMeSH+Terms%5D+OR+%22Jaundice%2Fchemically+induced%22%5BMeSH+Terms%5D+OR+%22Bile+Duct+Diseases%2Fchemically+induced%22%5BMeSH+Terms%5D+OR+%22Liver%2Fdrug+effects%22%5BMeSH+Terms%5D+OR+%22Liver+Diseases%2Fchemically+induced%22%5BMeSH+Terms%5D+%29+AND+%28%222021%2F01%2F01%22%5BDate+-+Publication%5D+%3A+%223000%22%5BDate+-+Publication%5D%29&schema=all)

2. Trials on Zilucoplan: from ClinicalTrials.gov (https://clinicaltrials.gov/ct2/results?term=Zilucoplan)